# Garcinia Cambogia

## OVERVIEW

### Introduction

Garcinia cambogia is an herbal product derived from the fruit of the Malabar tamarind tree native to Southeastern Asia which is used as a food preservative and flavoring agent and has recently been used increasingly in herbal weight loss products. Weight loss products labeled as containing Garcinia cambogia been linked to the development of clinically apparent acute liver injury which can be severe and even fatal.

### Background

Garcinia cambogia is an herbal product derived from fruit of the Malabar tamarind tree (also called Garcinia gummi-gutta) which is native to India, Nepal and Sri Lanka. The dried and smoked rind of the Garcinia cambogia fruit is commonly used as a food preservative and, because of its sharp, sour taste, as a flavoring agent and spice, especially in fish curries. The fruit rind has also been used in Ayurvedic medicine to treat gastrointestinal complaints and rheumatism. More recently, Garcinia cambogia has been purported to be an appetite suppressant effective in inducing weight loss. Chemical components of Garcinia extracts include xanthones, benzophenones, amino acids and organic acids, most importantly hydroxycitric acid (HCA) the suspected ingredient responsible for its antiinflammatory and appetite suppressant activity. Garcinia fruit is 10% to 30% HCA by weight, and extracts can contain between 20% and 60% of the tricarboxylic acid. HCA inhibits ATP citrate lyase an enzyme involved in fatty acid synthesis. Garcinia derivatives and HCA have been shown to cause appetite suppression and weight loss in rats, but the effects of these organic acids and Garcinia extracts have not been consistently found in human studies. Nevertheless, Garcinia cambogia is a frequent component of over-the-counter multiingredient herbal products and has been advertised as a weight loss product. Studies in rats and other animal models have suggested that Garcinia cambogia and HCA do not have significant toxicities, although testicular toxicity was found with high doses. In humans, Garcinia has been linked to rare reports of serotonin syndrome, rhabdomyolysis and hepatic toxicity, but the role of Garcinia as opposed to other components of the herbal products or mixtures typically used in humans has not been clearly defined.

### Hepatotoxicity

There have been at least a dozen reports of Garcinia induced liver injury in individuals taking multiingredient dietary supplements (MIDS) that contain Garcinia cambogia. In some instances, other known or suspected hepatotoxins were present in the MIDS products (such as with Exilis, Herbalife and Hydroxycut products). More recently, cases of acute liver injury have been identified in persons taking a product labelled as having Garcinia cambogia alone. The frequency of hepatic adverse reactions to Garcinia cambogia is not known but is likely uncommon and in less than 1:10,000 persons. Patients typically present with fatigue, nausea, elevations in serum aminotransferase levels, and jaundice 1 to 4 weeks after starting the product, although the latency to onset has been longer (3 to 12 months) in some cases. The pattern of enzyme elevations is hepatocellular, and immune features are not common. Some cases have been severe, resulting in acute liver failure and either death or need for urgent liver transplantation. Recurrence upon reexposure has not been clearly shown.

Likelihood score: B (likely rare cause of clinically apparent liver injury).

### Mechanism of Injury

The cause of hepatotoxicity from Garcinia cambogia is unclear. In vitro studies suggest that HCA may be toxic to the liver in high doses, but the rare instances of acute liver injury that occur with Garcinia cambogia suggest an idiosyncratic form of injury. The possibility of mislabeling or adulteration with hepatotoxic herbal products is always an issue in herbal related injury.

### Outcome and Management

The severity of liver injury ranges from transient and moderate enzyme elevations to symptomatic acute hepatitis to acute liver failure. In most instances, the liver injury subsides within 1 to 3 months of discontinuing the herbal product, but if fulminant hepatitis develops, a liver transplant may be required. Rechallenge should be avoided.

Other Names: Gamboge, Brindleberry, Malabar tamarind. There are at least 400 species of Garcinia other than cambogia (gummi-gutta) which may or may not have similar antiinflammatory and appetite suppressant activity or similar concentrations of HCA. Indeed, mislabeling other Garcinia species as cambogia may account for some instances of unexpected toxicity.

Drug Class: Herbal and Dietary Supplements

## CASE REPORT

### Case 1. Garcinia associated acute hepatitis.

[Modified from Case 1 in: Crescioli G, Lombardi N, Bettiol A, Marconi E, Risaliti F, Bertoni M, Menniti Ippolito F, et al. Acute liver injury following Garcinia cambogia weight-loss supplementation: case series and literature review. Intern Emerg Med 2018 May 25. [Epub ahead of print] PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/29802521)]

A 61 year old woman developed abdominal pain, nausea, dark urine and jaundice approximately 6 weeks after starting a weight loss product called Super Ananas Slim, which was labelled as containing Garcinia cambogia. She had no history of liver disease, alcohol abuse or exposure to hepatotoxins or acetaminophen. Her other medical conditions included history of cholecystectomy, dyslipidemia and hypothyroidism and her only other medication was levothyroxine. Two weeks after onset of symptoms, laboratory tests showed a serum bilirubin of 22.5 mg/dL (direct 16.7 mg/dL), ALT 1629 U/L, AST 1121 U/L, alkaline phosphatase 150 U/L and INR 2.2. She tested negative for hepatitis A, B and C and for routine autoantibodies. Despite stopping the herbal product, jaundice and symptoms worsened and persisted for several weeks, but ultimately resolved although serum aminotransferase levels remained mildly elevated 5 months later.

#### Key Points

Medication: | Garcinia cambogia
Pattern: | Hepatocellular (R=30)
Severity: | 4+ (jaundice and prolonged INR)
Latency: | 6 weeks
Recovery: | Slow, incomplete at 5 months
Other medications: | Levothyroxine

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
0 | Pre | Started Super Ananas Slim
2 months | 0 | 1629 | 150 | 22.5 | Admission
3 months | 3 weeks | 821 | 126 | 7.4 | Discharge
3.5 months | 6 weeks | 525 | 166 | 3.2
4 months | 9 weeks | 187 | 165 | 1.6
5 months | 3 months | 72 | 164 | 1.0
7 months | 5 months | 56 | 178 | 0.9
Normal Values | | <35 | <98 | <1.2

#### Comment

This patient developed a moderately severe acute hepatitis-like syndrome within 6 weeks of starting a multiingredient weight loss product called “Ananas Slim” which contained Garcinia cambogia as the primary ingredient, but it had other components including Ananas comosus (pineapple) and Ilex paraguariensis (Yerba mate), neither of which have been implicated in hepatotoxicity or other adverse effects. Similar to other reports of Garcinia associated liver injury, the latency to onset was rather brief (6 weeks) and the clinical features were an acute hepatocellular injury with significant jaundice and hepatic dysfunction. The injury was fairly severe and liver test abnormalities were still present 5 months later.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Garcinia Cambogia – Generic

DRUG CLASS

Herbal and Dietary Supplements

COMPLETE LABELING

Fact Sheet at National Center for Complementary and Integrative Health (https://nccih.nih.gov/health/garcinia)

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Garcinia Cambogia | 6205-14-7 | C6-H8-O8 | Garcinia Cambogia Chemical Structure

## ANNOTATED BIBLIOGRAPHY

References updated: 13 February 2019

Zimmerman HJ. Unconventional drugs. Miscellaneous drugs and diagnostic chemicals. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott,1999: pp. 731-4. (Expert review of hepatotoxicity published in 1999; several herbal medications linked to liver injury are discussed, but not Garcinia).
Seeff L, Stickel F, Navarro VJ. Hepatotoxicity of herbals and dietary supplements. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 631-58. (Review of hepatotoxicity of herbal and dietary supplements; does not mention Garcinia cambogia).
Heymsfield SB, Allison DB, Vasselli JR, Pietrobelli A, Greenfield D, Nunez C. Garcinia cambogia(hydroxycitric acid) as a potential antiobesity agent: a randomized controlled trial. JAMA 1998; 280: 1596-600. (Among 135 obese adults treated with HCA [1500 mg daily] or placebo for 12 weeks, weight loss was similar in the two groups [3.2 vs 4.1 kg] and adverse event rates were similar, and none led to early discontinuations; no mention of ALT testing or hepatotoxicity). 9820262
Russo MW, Galanko JA, Shrestha R, Fried MW, Watkins P. Liver transplantation for acute liver failure from drug-induced liver injury in the United States. Liver Transpl 2004; 10: 1018-23. (Among ~50,000 liver transplants reported to UNOS between 1990 and 2002, 270 [0.5%] were done for drug induced acute liver failure, including 7 [5%] for herbal medications, but none were attributed to Garcinia). 15390328
Andrade RJ, Lucena MI, Fernández MC, Pelaez G, Pachkoria K, García-Ruiz E, García-Muñoz B, et al. Drug-induced liver injury: an analysis of 461 incidences submitted to the Spanish Registry over a 10-year period. Gastroenterology 2005; 129: 512-21. (Reports of drug induced liver injury to a Spanish network found 570 cases, herbal medications accounted for 9 cases, but none were attributed to Garcinia). 16083708
Stevens T, Qadri A, Zein NN. Two patients with acute liver injury associated with use of the herbal weight-loss supplement hydroxycut. Ann Intern Med 2005; 142: 477-8. (27 and 30-year old men developed jaundice 2 and 5 weeks after starting a Hydroxycut product [bilirubin 7.8 and 7.8 mg/dL, ALT 3131 and 45 U/L, Alk P 171 and 530 U/L], resolving in 5 weeks). 15767636
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008, 9% of cases were attributed to herbal medications, but Garcinia cambogia was not specifically mentioned). 18955056
García-Cortés M, Borraz Y, Lucena MI, Peláez G, Salmerón J, Diago M, Martínez-Sierra MC, et al. [Liver injury induced by "natural remedies": an analysis of cases submitted to the Spanish Liver Toxicity Registry]. Rev Esp Enferm Dig 2008; 100: 688-95. Spanish. (Among 521 cases of drug induced liver injury submitted to Spanish registry, 13 [2%] were due to herbals, none of which were attributed to Garcinia cambogia). 19159172
Chitturi S, Farrell GC. Hepatotoxic slimming aids and other herbal hepatotoxins. J Gastroenterol Hepatol 2008; 23: 366-73. (General review of herbal weight loss agents and hepatotoxicity includes discussions of green tea, LipoKinetix, Ma Huang and usnic acid, but not Garcinia cambogia). 18318821
Navarro VJ. Herbal and dietary supplement hepatotoxicity. Semin Liver Dis 2009; 29: 373-82. (Review of the problems of causality assessment in herbal and dietary supplement [HDS] associated liver disease, including the variable clinical presentations, the complexity and lack of information on their components, absence of controlled trials demonstrating safety and efficacy, the possibility of contamination or incorrect labeling and frequent underreporting of herbal use by patients. Regulation of HDS is under DSHEA, which requires manufacturers to determine safety and prohibits claims of efficacy in treating specific diseases. The US Pharmacopeia sets standards for food and drugs and includes HDS; HDS induced liver injury is a growing problem and currently accounts for at least 10% of cases of acute liver injury due to medications). 19826971
Jacobsson I, Jönsson AK, Gerdén B, Hägg S. Spontaneously reported adverse reactions in association with complementary and alternative medicine substances in Sweden. Pharmacoepidemiol Drug Saf 2009; 18: 1039-47. (Review of 778 reports of adverse reactions to herbals to a Swedish Registry; no mention of Garcinia). 19650152
Lobb A. Hepatoxicity associated with weight-loss supplements: a case for better post-marketing surveillance. World J Gastroenterol 2009; 15: 1786-7. (Commentary on liver injury due to Hydroxycut products which contained Garcinia cambogia, summarized 6 cases in the published literature and drew attention to its hepatotoxicity and the need for better regulation and surveillance of HDS safety). 19360927
McDonnell WM, Bhattacharya R, Halldorson JB. Fulminant hepatic failure after use of the herbal weight-loss supplement exilis. Ann Intern Med 2009; 151: 673-4. (25 year old man developed severe hepatitis 2 weeks after starting Exilis, a multiingredient dietary supplement similar to Hydroxycut in ingredients, including green tea and Garcinia cambogia [bilirubin 10.8 rising to 28.0 mg/dL, ALT 2362 U/L, INR rising to 3.4], ultimately requiring liver transplantation). 19884634
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 [11%] were attributed to drug induced liver injury of which 12 [9%] were due to HDS, including several herbal mixtures, usnic acid, Ma Huang, black cohosh, and Hydroxycut; the possible role of Garcinia cambogia was not discussed). 20949552
Chen GC, Ramanathan VS, Law D, Funchain P, Chen GC, French S, Shlopov B, et al. Acute liver injury induced by weight-loss herbal supplements. World J Hepatol 2010; 2: 410-5. (Report of 3 cases of acute liver injury in patients taking weight loss supplements, one due to Hydroxycut and two to Herbalife products discussing the possible role of green tea, but not Garcinia cambogia extracts in causing the injury). 21173910
Stickel F, Kessebohm K, Weimann R, Seitz HK. Review of liver injury associated with dietary supplements. Liver Int 2011; 31: 595-605. (Review of liver injury from HDS focusing upon Herbalife and Hydroxycut products, green tea, usnic acid, Noni juice, and Chinese herbs, mentions that Garcinia cambogia was a primary component of Hydroxycut products before 2009). 21457433
Onakpoya I, Hung SK, Perry R, Wider B, Ernst E. The use of Garcinia extract(hydroxycitric acid) as a weight loss supplement: a systematic review and meta-analysis of randomised clinical trials. J Obes 2011; 2011: 509038. (A systematic review of published randomized controlled trials of HCA as a weight loss agent identified 12 studies with a total of 706 subjects, found evidence of a slight effect [-0.9 kg] that was marginally significant compared to placebo while adverse events were similar between the two groups; no mention of ALT elevations or hepatotoxicity). 21197150
Teschke R, Wolff A, Frenzel C, Schulze J, Eickhoff A. Herbal hepatotoxicity: a tabular compilation of reported cases. Liver Int 2012 32: 1543-56. (A systematic compilation of all publications on the hepatotoxicity of specific herbals identified 185 publications on 60 different herbs and supplements, including Garcinia cambogia which was a component of 3 proprietary multiingredient products: Herbalife, Hydroxycut and Exilis). 22928722
Márquez F, Babio N, Bulló M, Salas-Salvadó J. Evaluation of the safety and efficacy of hydroxycitric acid or Garcinia cambogia extracts in humans. Crit Rev Food Sci Nutr 2012; 52: 585-94. (Review of studies in animals and humans on efficacy and safety of Garcinia cambogia as a weight loss agent; mentions that adverse effects from Garcinia extracts are uncommon and mild in humans, but that the hepatotoxicity associated with the dietary supplement Hydroxycut has been purported to be caused by the Garcinia, although the association is unproven). 22530711
Teschke R, Schulze J, Schwarzenboeck A, Eickhoff A, Frenzel C. Herbal hepatotoxicity: suspected cases assessed for alternative causes. Eur J Gastroenterol Hepatol 2013; 25: 1093-8. (Review of literature of case series of suspected HDS related liver injury found evidence of other explanations in 19 of 23 publications, involving 278 of 573 patients [49%] and these other diagnoses weakened the causality assessment in most instances; no mention of Garcinia cambogia related cases). 23510966
Bunchorntavakul C, Reddy KR. Review article: herbal and dietary supplement hepatotoxicity. Aliment Pharmacol Ther 2013; 37: 3-17. (Systematic review of literature on HDS associated liver injury discusses Herbalife and Hydroxycut products but does not mention the possible role of Garcinia cambogia). 23121117
Rossi S, Navarro VJ. Herbs and liver injury: a clinical perspective. Clin Gastroenterol Hepatol 2014; 12: 1069-76. (Review of HDS induced liver injury including regulatory problems, difficulties in diagnosis and causality assessment; mentions Herbalife products as being implicated in case series of liver injury from Israel, Switzerland and Spain and Hydroxycut products as having been implicated in many cases and the formulation changed but does not specifically mention or discuss Garcinia). 23924877
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology 2013; 144: 1419-25. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period including 15 attributed to HDS products, none of which were attributed to Garcinia cambogia). 23419359
Licata A, Macaluso FS, Craxì A. Herbal hepatotoxicity: a hidden epidemic. Intern Emerg Med 2013; 8: 13-22. (Review and commentary on herbal hepatotoxicity discusses pyrrolizidine alkaloids, green tea, Echinacea, kava, usnic acid, ephedra and products made by Herbalife, Hydroxycut and LipoKinetix and lists Garcinia cambogia as a possible culprit in Hydroxycut products that caused hepatitis). 22477279
Navarro VJ, Seeff LB. Liver injury induced by herbal complementary and alternative medicine. Clin Liver Dis 2013; 17: 715-35. (Review of HDS induced liver injury including regulatory problems, difficulties in diagnosis and causality assessment; mentions Herbalife and Hydroxycut products but does not mention Garcinia cambogia). 24099027
Dağ MS, Aydınli M, Oztürk ZA, Türkbeyler IH, Koruk I, Savaş MC, Koruk M, et al. Drug- and herb-induced liver injury: a case series from a single center. Turk J Gastroenterol 2014; 25: 41-5. (Between 2008 and 2012, 82 patients with drug or herbal supplement induced liver injury were seen at a single referral center in Turkey, 10 [12%] of which were due to HDS products, including 7 due to Teucrium polium [mountain germander] and 3 to green tea, but none to Garcinia cambogia). 24918129
Teschke R, Genthner A, Wolff A, Frenzel C, Schulze J, Eickhoff A. Herbal hepatotoxicity: Analysis of cases with initially reported positive re-exposure tests. Dig Liver Dis 2014; 46: 264-9. (Reanalysis of 34 published cases of liver injury due to herbal medications in which there was a reported positive rechallenge, finding only 21 [62%] fulfilled the criteria of a positive rechallenge using RUCAM, the others having inconsistent [18%] or incomplete data [21%]; none of the 34 cases were initially attributed to Garcinia cambogia). 24315480
Navarro VJ, Barnhart H, Bonkovsky HL, Davern T, Fontana RJ, Grant L, Reddy KR, et al. Liver injury from herbals and dietary supplements in the U.S. Drug-Induced Liver Injury Network. Hepatology 2014; 60: 1399-408. (Among 85 cases of HDS associated liver injury [not due to anabolic steroids] enrolled in a US prospective study between 2004 and 2013, Garcinia was not mentioned among the implicated agents, although some were MIDS that list Garcinia as a component [Xenadrine, Hydroxycut). 25043597
Navarro VJ, Lucena MI. Hepatotoxicity induced by herbal and dietary supplements. Semin Liver Dis 2014; 34: 172-93. (Review of HDS induced liver injury including regulatory problems, difficulties in diagnosis and causality assessment, discusses Herbalife and Hydroxycut products, but does not specifically mention Garcinia cambogia as a component of these proprietary products that might be responsible for their hepatotoxicity). 24879982
Korth C. Drug-induced hepatotoxicity of select herbal therapies. J Pharm Pract 2014; 27: 567-72. (Review of liver injury due to selected HDS discusses the literature implicating kava, green tea, germander, pyrrolizidine alkaloids and Herbalife products, but does not specifically mention Garcinia cambogia). 25546878
Semwal RB, Semwal DK, Vermaak I, Viljoen A. A comprehensive scientific overview of Garcinia cambogia. Fitoterapia 2015; 102: 134-48. (Comprehensive review of Garcinia cambogia including its botanical features, geographic distribution, ethnobotanical use, phytochemistry, biologic activity, clinical uses and toxicity, including testicular injury with high doses in rats, serotonin toxicity reported in humans and rare cases of hepatotoxicity in humans which was reported largely with use of Hydroxycut products). 25732350
Seeff LB, Bonkovsky HL, Navarro VJ, Wang G. Herbal products and the liver: a review of adverse effects and mechanisms. Gastroenterology 2015; 148: 517-32. (Extensive review of possible beneficial as well as harmful effects of herbal products on the liver; mentions that multiingredient supplements have been implicated in many cases of liver injury including proprietary agents marketed under the names Herbalife, Hydroxycut and OxyELITE Pro, but does not specifically discuss or mention Garcinia cambogia). 25500423
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52. (Among 899 cases of drug induced liver injury enrolled in a prospective database between 2004 and 2012, HDS were implicated in 145 [16%], the single major herbal cause being green tea and no cases clearly implicating Garcinia cambogia). 25754159
Stickel F, Shouval D. Hepatotoxicity of herbal and dietary supplements: an update. Arch Toxicol 2015; 89: 851-65. (Extensive review of liver injury due to HDS; mentions that Herbalife has been implicated in 54 cases of liver injury, 7 with a positive rechallenge, but that the cause of the injury remains unknown and that few cases have been published since 2011). 25680499
Melendez-Rosado J, Snipelisky D, Matcha G, Stancampiano F. Acute hepatitis induced by pure Garcinia cambogia. J Clin Gastroenterol 2015; 49: 449-50. (42 year old woman developed severe abdominal pain one week after starting Garcinia cambogia for weight loss and while taking hydralazine for hypertension and acetaminophen/hydrocodone for back pain [bilirubin 0.3 mg/dL, ALT 1277 U/L, Alk P 283 U/L, INR 1.3], with rapid recovery on stopping all medications). 25811114
Corey R, Werner KT, Singer A, Moss A, Smith M, Noelting J, Rakela J. Acute liver failure associated with Garcinia cambogia use. Ann Hepatol 2016; 15: 123-6. (52 year old woman developed anorexia and fatigue followed by jaundice 3-4 weeks after starting Garcinia cambogia [1000 mg daily] [bilirubin 8.5 mg/dL, ALT 645 U/L, Alk P 140 U/L, INR 3.2], progressing to hepatic failure and emergency liver transplantation). 26626648
García-Cortés M, Robles-Díaz M, Ortega-Alonso A, Medina-Caliz I, Andrade RJ. Hepatotoxicity by dietary supplements: a tabular listing and clinical characteristics. Int J Mol Sci 2016; 17: 537. (Listing of published cases of liver injury from HDS products including Hydroxycut that contains Garcinia cambogia and several cases in which Garcinia was taken alone [Corey 2016 and Melendez-Rosado 2015]). 27070596
Avigan MI, Mozersky RP, Seeff LB. Scientific and regulatory perspectives in herbal and dietary supplement associated hepatotoxicity in the United States. Int J Mol Sci 2016; 17: 331. (Overview of the US regulations regarding herbal and dietary supplements and role of FDA, Department of Agriculture, Federal Trade Commission and Office of Dietary Supplements of the NIH in assessment of safety of HDS products including actions taken against Hydroxycut which contained Garcinia cambogia extract and resulted in the change in its formulation, but cases of liver injury continued to be reported [Araujo 2015]). 26950122
Marcus DM. Dietary supplements: What's in a name? What's in the bottle? Drug Test Anal 2016; 8 (3-4): 410-2. (Commentary on regulation of HDS products concludes: "the marketing of botanical supplements is based on unfounded claims that they are safe and effective", and "there is no reason to take herbal medicines whose composition and benefits are unknown and whose risks are evident"). 27072845
Lunsford KE, Bodzin AS, Reino DC, Wang HL, Busuttil RW. Dangerous dietary supplements: Garcinia cambogia-associated hepatic failure requiring transplantation. World J Gastroenterol 2016; 22: 10071-6. (34 year old man developed nausea and jaundice 5 months after starting a Garcinia cambogia extract for weight loss [bilirubin 34.7 mg/dL, ALT 520 U/L, Alk P 156 U/L, INR 3.5], with progression to liver failure and successful emergency liver transplantation). 28018115
Brown AC. An overview of herb and dietary supplement efficacy, safety and government regulations in the United States with suggested improvements. Part 1 of 5 series. Food Chem Toxicol 2017; 107 (Pt A): 449-71. (Summary of the US regulations on safety and efficacy of herbal and dietary supplements, lists Garcinia cambogia as accepted into the US Pharmacopoeia monograph development process as an agent for which “available evidence does not indicate a serious risk to health”). 27818322
Brown AC. Liver toxicity related to herbs and dietary supplements: Online table of case reports. Part 2 of 5 series. Food Chem Toxicol 2017; 107 (Pt A): 472-501. (Description of an online compendium of cases of liver toxicity attributed to HDS products, lists Exilis and Hydroxycut as containing Garcinia cambogia, among other ingredients). 27402097
Wong LL, Lacar L, Roytman M, Orloff SL. Urgent liver transplantation for dietary supplements: an under-recognized problem. Transplant Proc 2017; 49: 322-5. (Among 2048 adult liver transplants recipients enrolled in the Scientific Registry of Transplant Recipients [SRTR] between 2003 and 2015, 625 were done for acute hepatic necrosis due to drug induced liver injury, half being due to acetaminophen and the 4th most frequent cause [n=21] being HDS products, while Garcinia cambogia is not specifically listed, 1 case was attributed to Hydroxycut and many listed merely as “herbal medicine” or “unknown herbals”). 28219592
de Boer YS, Sherker AH. Herbal and dietary supplement-induced liver injury. Clin Liver Dis 2017; 21: 135-49. (Review of the frequency, clinical features, patterns of injury and outcomes of HDS hepatotoxicity with specific mention of anabolic steroids, black cohosh, germander, green tea, kava, pyrrolizidine alkaloids and proprietary multiingredient dietary supplements [MIDS]; mentions that Garcinia cambogia is an ingredient of some Herbalife products). 27842768
Vega M, Verma M, Beswick D, Bey S, Hossack J, Merriman N, Shah A, et al.; Drug Induced Liver Injury Network (DILIN). The incidence of drug- and herbal and dietary supplement-induced liver injury: preliminary findings from gastroenterologist-based surveillance in the population of the State of Delaware. Drug Saf 2017; 40: 783-7. (A prospective, population based registry of cases of drug induced liver injury occurring in Delaware during 2014, identified 20 cases [2.7 per 100,000] overall, including 6 due to HDS products, and one of which was attributed to Garcinia cambogia). 28555362
Navarro VJ, Khan I, Björnsson E, Seeff LB, Serrano J, Hoofnagle JH. Liver injury from herbal and dietary supplements. Hepatology 2017; 65: 363-73. (Review of the problems of liver injury and HDS products, specifically discusses anabolic steroids, green tea extract and OxyELITE Pro, but does not discuss Garcinia cambogia). 25043597
Sharma A, Akagi E, Njie A, Goyal S, Arsene C, Krishnamoorthy G, Ehrinpreis M. Acute hepatitis due to Garcinia cambogia extract, an herbal weight loss supplement. Case Rep Gastrointest Med 2018; 2018: 9606171. (57 year old woman developed abdominal pain 1 month after starting Garcinia cambogia for weight loss [bilirubin 2.4 mg/dL, ALT 738 U/L, Alk P 80 U/L, INR 1.2], resolving within a month of stopping and ALT rising again [301 U/L] after restarting). 30147968
Kothadia JP, Kaminski M, Samant H, Olivera-Martinez M. Hepatotoxicity associated with use of the weight loss supplement Garcinia cambogia: a case report and review of the literature. Case Reports Hepatol 2018; 2018: 6483605. (36 year old woman developed fatigue and jaundice 4 weeks after starting Garcinia cambogia for weight loss [bilirubin 7.4 mg/dL, ALT 5615, Alk P 104 U/L]). 29721342
Gavrić A, Ribnikar M, Šmid L, Luzar B, Štabuc B. Fat burner-induced acute liver injury: Case series of four patients. Nutrition 2018; 47: 110-4. (4 case reports of acute liver injury attributed to “fat burners” used for weight loss, including spirulina [Case #1], green tea [#2], green coffee bean [#3] and a combination of green tea and Garcinia cambogia). 29310849
Crescioli G, Lombardi N, Bettiol A, Marconi E, Risaliti F, Bertoni M, Menniti Ippolito F, et al. Acute liver injury following Garcinia cambogia weight-loss supplementation: case series and literature review. Intern Emerg Med 2018 May 25. [Epub ahead of print] (Four cases of acute liver injury associated with weight loss supplements, one due to spirulina, one to green tea, one to green coffee bean and one to a product with both green tea and Garcinia cambogia extract). 29802521
Licata A, Minissale MG. Weight-loss supplementation and acute liver failure: the case of Garcinia Cambogia. Intern Emerg Med 2018; 13: 833-5. (Editorial in response to Crescioli [2018] summarizing the literature on Garcinia cambogia associated liver injury). 30032342

## OTHER REFERENCE LINKS

1. Recent References on Garcinia Cambogia: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Garcinia%20Cambogia+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Garcinia Cambogia: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Garcinia%20Cambogia)